# Fostamatinib

## OVERVIEW

### Introduction

Fostamatinib is an orally available small molecule inhibitor of spleen tyrosine kinase that is used to treat chronic immune thrombocytopenia. Fostamatinib is associated with transient and usually mild elevations in serum aminotransferase levels during therapy but has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Fostamatinib (fos" ta ma' ti nib) is an orally available, specific inhibitor of spleen tyrosine kinase that is used to treat chronic immune mediated thrombocytopenia. The spleen tyrosine kinase (Syk) signaling pathway is important in phagocytosis and specifically the antibody mediated uptake and destruction of platelets by splenic macrophages in patients with immune thrombocytopenia. The Syk signaling pathway may also play a role in other immune cell types involved in inflammation and cell damage. Fostamatinib was been shown to raise platelet counts in patients with refractory chronic immune thrombocytopenia and was approved for this use in the United States in 2018. Fostamatinib has also been evaluated in patients with rheumatoid arthritis, autoimmune hemolytic anemia and other immune-mediated conditions, but has not been specifically approved for these uses. Fostamatinib is available in tablets of 50 and 100 mg under the brand name Tavalisse. The recommended initial dose is 100 mg twice daily, increasing to 150 mg twice daily after 4 weeks as needed. Common side effects include diarrhea, nausea, abdominal pain, hypertension, dizziness, chest pain, neutropenia and rash. Rare, but potentially severe adverse events include, severe diarrhea, hypertension, neutropenia and embryo-fetal toxicity.

### Hepatotoxicity

In prelicensure controlled trials, serum aminotransferase elevations above 3 times ULN arose in 9% of fostamatinib treated subjects but in none of the placebo recipients. ALT values above 5 times ULN occurred in 5% of treated subjects. These elevations were typically transient but led to early discontinuations in a proportion of patients, but more often resolved even without dose adjustment. In prelicensure studies, there were no instances of clinically apparent liver injury attributed to fostamatinib. Since approval and more widescale availability of fostamatinib, there have been no published reports of hepatotoxicity associated with its use, although it has had limited general use.

Likelihood score: E* (suspected but unproven cause of idiosyncratic clinically apparent liver injury).

### Mechanism of Injury

The causes of serum enzyme elevations during fostamatinib therapy are not known. Fostamatinib is metabolized in the liver largely by CYP 3A4 and liver injury may be related to production of a toxic or immunogenic intermediate. Because it is a substrate for CYP 3A4, fostamatinib is susceptible to drug-drug interactions with agents that inhibit or induce this specific hepatic microsomal activity.

### Outcome and Management

Monitoring of serum aminotransferase levels is recommended for patients before starting fostamatinib and at monthly intervals thereafter. Serum aminotransferase elevations above 5 times the upper limit of normal or any elevations accompanied by jaundice or symptoms should lead to discontinuation. There does not appear to be cross reactivity in risk for hepatic injury between fostamatinib and other kinase inhibitors.

Drug Class: Hematologic Growth Factors, Protein Kinase Inhibitors

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fostamatinib – Tavalisse®

DRUG CLASS

Hematologic Growth Factors

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?label=all&query=Fostamatinib)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Fostamatinib | 901119-35-5 | C23-H26-F-N6-O9-P | Fostamatinib structure

## ANNOTATED BIBLIOGRAPHY

References updated: 20 October 2018

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Review of hepatotoxicity published in 1999 before the availability of protein kinase inhibitors such as fostamatinib).
DeLeve LD. Erlotinib. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 556. (Review of hepatotoxicity of cancer chemotherapeutic agents discusses several kinase inhibitors including imatinib, gefitinib, erlotinib and crizotinib, but not fostamatinib).
Chabner BA, Barnes J, Neal J, Olson E, Mujagic H, Sequist L, Wilson W, et al. Targeted therapies: tyrosine kinase inhibitors, monoclonal antibodies, and cytokines. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1731-54. (Textbook of pharmacology and therapeutics).
https://www.accessdata.fda.gov/scripts/cder/daf/ (FDA Drug Approvals website that has product labels [package inserts], letters of approval and full FDA scientific review of the new drug application for safety and efficacy).
Spraggs CF, Xu CF, Hunt CM. Genetic characterization to improve interpretation and clinical management of hepatotoxicity caused by tyrosine kinase inhibitors. Pharmacogenomics 2013; 14: 541-54. (Review of genetic associations of serum ALT and bilirubin elevations during therapy with tyrosine kinase inhibitors focusing on lapatinib and pazopanib; fostamatinib is not mentioned). 23556451
Genovese MC, van der Heijde DM, Keystone EC, Spindler AJ, Benhamou C, Kavanaugh A, Fudman E, et al. A phase III, multicenter, randomized, double-blind, placebo-controlled, parallel-group study of 2 dosing regimens of fostamatinib in patients with rheumatoid arthritis with an inadequate response to a tumor necrosis factor-α antagonist. J Rheumatol 2014; 41: 2120-8. (Among 323 patients with rheumatoid arthritis on methotrexate enrolled in a randomized controlled trial for 24 weeks, clinical responses were more frequent with fostamatinib [36% and 28%] than placebo [21%], but so were side effects including diarrhea [20% and 27% vs 6%] and hypertension [13% and 14% vs 8%] and ALT elevations above 3 times ULN [4% and 2% vs 2%], and there were no liver related serious adverse events). 25225285
Taylor PC, Genovese MC, Greenwood M, Ho M, Nasonov E, Oemar B, Stoilov R, et al. OSKIRA-4: a phase IIb randomised, placebo-controlled study of the efficacy and safety of fostamatinib monotherapy. Ann Rheum Dis 2015; 74: 2123-9. (Among 279 patients with rheumatoid arthritis treated with fostamatinib or adalimumab or placebo for 6 weeks, clinical improvements were more frequent with fostamatinib than placebo as were adverse events, ALT elevations above 5 times ULN occurring in 4% vs 2% on placebo). 25074688
Bussel J, Arnold DM, Grossbard E, Mayer J, Treliński J, Homenda W, Hellmann A, et al. Fostamatinib for the treatment of adult persistent and chronic immune thrombocytopenia: results of two phase 3, randomized, placebo-controlled trials. Am J Hematol 2018; 93: 921-30. (Among 150 patients enrolled in 2 controlled trials of a 24-week course of fostamatinib in patients with chronic immune thrombocytopenia, response in platelet counts were more frequent with fostamatinib vs placebo [43% vs 14%] as were adverse side effects including ALT elevations [11% vs 0%], but there were no cases of clinically apparent liver injury in either group). 29696684
Newland A, Lee EJ, McDonald V, Bussel JB. Fostamatinib for persistent/chronic adult immune thrombocytopenia. Immunotherapy 2018; 10: 9-25. (Review of the basis of use, clinical efficacy and safety of fostamatinib in therapy of immune thrombocytopenia mentions that ALT elevations above twice normal occur in up to 12% of patients, but are generally mild and transient and not accompanied by symptoms or jaundice). 28967793
Markham A. Fostamatinib: first global approval. Drugs 2018; 78: 959-63. (Review of the history of the development of fostamatinib, its mechanism of action, pharmacology, clinical efficacy and safety). 29869203

## OTHER REFERENCE LINKS

1. Recent References on Fostamatinib: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Fostamatinib+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Fostamatinib: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Fostamatinib)